# Antineoplastic Agents

## OVERVIEW

The antineoplastic agents or anticancer drugs represent a large and diverse class of medications. They generally have limited but important uses, and often have significant hepatotoxicity.

The antineoplastic agents are not easily classified. Historically, they are categorized as (1) alkylating agents, (2) antimetabolites, (3) natural products, (4) hormones and antagonists, and (5) miscellaneous. In recent years, however, the miscellaneous group has come to include some of the most important agents. Anticancer agents can also be classified by indication (lymphoma, leukemia, melanoma, solid tumor), mechanism of action (such as alkylating agents, antibiotics, biological response modifiers, antiandrogens, topoisomerase inhibitors or protein kinase inhibitors), chemical structure (folic acid analog, platinum coordination complex, purine or pyrimidine analog, monoclonal antibody) or as cytotoxic or nonspecific vs noncytotoxic or targeted. The classification used in LiverTox represents a mixture of these systems, which generally follow those given in modern pharmacology textbooks.

Almost all antineoplastic agents have some degree of hepatotoxicity, and the liver injury is usually due to direct, intrinsic toxicity. The typical manifestation is an elevation in liver enzymes or bilirubin during therapy that reverses rapidly with stopping treatment or dose modification. This type of hepatotoxicity is dose related and generally self-limiting, but can be severe, progressive and even fatal as can occur with sinusoidal obstruction syndrome or acute toxic hepatic injury. The antineoplastic agents often have a narrow toxic-therapeutic ratio, although the usual dose limiting toxicity is myelosuppression. Nevertheless, liver injury also can be dose limiting, which generally becomes clear in early dose finding studies. For this reason, many antineoplastic agents acquire a reputation for hepatotoxicity based upon premarketing studies, but are later found to be reasonably well tolerated and only rare causes of clinically significant liver injury when given in lower doses. Antineoplastic agents that are well known to cause significant direct hepatotoxicity when given in moderate to high doses (particularly when used in myeloablation before hematopoietic cell transplantation) include busulfan, melphalan, cyclophosphamide, dacarbazine, cytarabine, fluorouracil, carboplatin and L-asparaginase. At lower doses, these agents are well tolerated.

Some antineoplastic agents can also cause idiosyncratic liver injury due to immunologic or metabolic idiosyncrasy. Thus, typical drug induced cholestatic liver injury can occur in rare instances after therapy with cyclophosphamide, azathioprine, mercaptopurine, melphalan and temozolomide. Acute hepatocellular injury can occur with flutamide, bicalutamide and thalidomide. Steatohepatitis can occur with L-asparaginase, methotrexate and tamoxifen (although this pattern may be due to direct toxicity rather than idiosyncratic injury). Selected anticancer agents have also been linked to immunoallergic hepatitis or to autoimmune hepatitis-like injury. A distinctive autoimmune pattern is found in rare instances after monoclonal antibody therapies or with the protein kinase inhibitors. The pathogenesis of these immune reactions is not always well understood. Finally, some antineoplastic agents can cause reactivation of hepatitis B, exacerbations of chronic hepatitis C, or lead to decompensation of an preexisting cirrhosis.

A classification of the antineoplastic agents with listing of individual agents is given below. There has been a steady increase in development of innovative antineoplastic agents in recent years and between 5 and 10 new anticancer agents are approved yearly. The hepatotoxicity of these recently introduced agents has not always been well defined. The following links are to individual drug records for the antineoplastic agents; those that are not underlined have yet to be added.

### Antineoplastic Agents

- Alkylating Agents
  - Altretamine, Bendamustine, Busulfan, Carmustine, Chlorambucil, Cyclophosphamide, Dacarbazine, Ifosfamide, Lomustine, Lurbinectedin, Mechlorethamine, Melphalan, Procarbazine, Streptozocin, Temozolomide, Thiotepa, Trabectedin
  - Platinum Coordination Complexes
    - Carboplatin, Cisplatin, Oxaliplatin
- Antibiotics, Cytotoxic
  - Bleomycin, Dactinomycin, Daunorubicin, Doxorubicin, Epirubicin, Idarubicin, Mitomycin, Mitoxantrone, Plicamycin, Valrubicin
- Antimetabolites
  - Antifolates: Methotrexate, Pemetrexed, Pralatrexate, Trimetrexate
  - Purine Analogues: Azathioprine, Cladribine, Fludarabine, Mercaptopurine, Thioguanine
  - Pyrimidine Analogues: Azacitidine, Capecitabine, Cytarabine, Decitabine, Floxuridine, Fluorouracil, Gemcitabine, Trifluridine/Tipracil
- Biologic Response Modifiers
  - Aldesleukin (IL-2), Denileukin Diftitox, Interferon Gamma
- Histone Deacetylase Inhibitors
  - Belinostat, Panobinostat, Romidepsin, Vorinostat
- Hormonal Agents
  - Antiandrogens: Abiraterone, Apalutamide, Bicalutamide, Cyproterone, Enzalutamide, Flutamide, Nilutamide
  - Antiestrogens (including Aromatase Inhibitors): Anastrozole, Exemestane, Fulvestrant, Letrozole, Raloxifene, Tamoxifen, Toremifene
  - Gonadotropin Releasing Hormone Analogues: Degarelix, Goserelin, Histrelin, Leuprolide, Relugolix, Triptorelin
  - Peptide Hormones: Lanreotide, Octreotide, Pasireotide
- Monoclonal Antibodies
  - Alemtuzumab, Amivantamab, Atezolizumab, Avelumab, Belantamab, Bevacizumab, Blinatumomab, Brentuximab, Cemiplimab, Cetuximab, Daratumumab, Dinutuximab, Dostarlimab, Durvalumab, Elotuzumab, Enfortumab, Gemtuzumab, Inotuzumab Ozogamicin, Ipilimumab, Margetuximab, Mogamulizumab, Moxetumomab Pasudotox, Naxitamab, Necitumumab, Nivolumab, Ofatumumab, Olaratumab, Panitumumab, Pembrolizumab, Pertuzumab, Polatuzumab Vedotin, Ramucirumab, Rituximab, Sacituzumab Govitecan, Tafasitamab, Teclistamab, Tisotumab Vedotin, Tositumomab, Trastuzumab, Trastuzumab Deruxtecam, Trastuzumab Emtansine, Tremelimumab
- Protein Kinase Inhibitors
  - Abemaciclib, Acalabrutinib, Adagrasib, Afatinib, Alectinib, Alpelisib, [underlined: Asciminib], Axitinib, Binimetinib, Bortezomib, Bosutinib, Brigatinib, Cabozantinib, Capivasertib, Capmatinib, Carfilzomib, Ceritinib, Cobimetinib, Copanlisib, Crizotinib, Dabrafenib, Dacomitinib, Dasatinib, Duvelisib, Enasidenib, Encorafenib, Ensartinib, Entrectinib, Erdafitinib, Erlotinib, Fedratinib, Fruquintinib, Futibatinib, Gefitinib, Gilteritinib, Glasdegib, Ibrutinib, Idelalisib, Imatinib, Infigratinib, Inavolisib, Ivosidenib, Ixazomib, Lapatinib, Larotrectinib, Lazertinib, Lenvatinib, Lorlatinib, Midostaurin, Mobocertinib, Momelotinib, Neratinib, Nilotinib, Niraparib, Olaparib, Olutasidenib, Osimertinib, Pacritinib, Palbociclib, Pazopanib, Pemigatinib, Pexidartinib, Pirtobrutinib, Ponatinib, Quizartinib, Regorafenib, Repotrectinib, Revumenib, Ribocicib, Ripretinib, Rucaparib, Ruxolitinib, Selumetinib, Sonidegib, Sorafenib, Sunitinib, Talazoparib, Tivozanib, Tovorafenib, Trametinib, Trilaciblib, Umbralisib, Vandetanib, Vemurafenib, Vismodegib, Zanubrutinib
- Taxanes
  - Cabazitaxel, Docetaxel, Paclitaxel
- Topoisomerase Inhibitors
  - Etoposide, Irinotecan, Teniposide, Topotecan
- Vinca Alkaloids
  - Vinblastine, Vincristine, Vinorelbine
- Miscellaneous
  - Asparaginase (Pegaspargase), Belzutifan, Bexarotene, Cedazuridine, Eribulin, Everolimus, Hydroxyurea, Ixabepilone, Lenalidomide, Mitotane, Omacetaxine, Pomalidomide, Selinexor, Tagraxofusp, Tazemetostat, Tebentafusp, Telotristat, Temsirolimus, Thalidomide, Venetoclax

## ANNOTATED BIBLIOGRAPHY

References updated: 01 May 2019

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 541-67. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013).
Wellstein A. General principles in the pharmacotherapy of cancer. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1161-6. (Textbook of pharmacology and therapeutics).